# Haloperidol

## OVERVIEW

### Introduction

Haloperidol is a conventional antipsychotic agent used in the treatment of acute and chronic psychosis. Haloperidol therapy is commonly associated with minor serum aminotransferase elevations and in very rare instances has been linked to clinically apparent acute liver injury.

### Background

Haloperidol (hal" oh per' i dol) is a butyrophenone derivative which appears to act as a dopamine type 2 (D2) receptor antagonist, but has other central and peripheral effects. Haloperidol is indicated for the therapy of acute and chronic psychoses and for controlling tics and vocal utterances in Tourette syndrome. Haloperidol is also used for short-term treatment of severe behavior problems in children with hyperactivity. Haloperidol was approved for use in the United States in 1967, but is currently infrequently used, having been replaced in large part by the atypical antipsychotics, which have fewer extrapyramidal side effects. Haloperidol is available as tablets of 0.5, 1, 2, 5, 10 and 20 mg, as an oral solution and in several formulations for parenteral use in generic forms and under the brand names Haldol and Peridol. The dose of haloperidol ranges considerably based upon patient age, severity of illness and concomitant medications. The typical range of maintenance doses in adults is 0.5 to 5 mg two to three times daily. Common side effects include drowsiness, restlessness, dizziness, headache, blurred vision, tremor and weight gain. Rare, but potentially severe adverse events include cardiovascular events, QTc prolongation, tardive dyskinesia, neuroleptic malignant syndrome and embryo-fetal toxicity.

### Hepatotoxicity

Liver test abnormalities have been reported to occur in 20% of patients on long term therapy with haloperidol, but elevations are uncommonly above 3 times the upper limit of normal. The aminotransferase abnormalities are usually mild, asymptomatic and transient, reversing even with continuation of medication. Instances of clinically apparent acute liver injury have been reported due to haloperidol, but they are uncommon. The onset of jaundice is within 2 to 6 weeks, and the pattern of serum enzyme elevations is typically cholestatic or mixed. Signs of hypersensitivity (fever, rash and eosinophilia) have been reported in some cases, but they are usually mild and self-limited; autoantibodies are rare.

Likelihood score: B (likely cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which haloperidol causes serum aminotransferase elevations is not known, but is likely due to production of a toxic intermediate of its metabolism. Haloperidol is extensively metabolized by the liver via sulfoxidation and oxidation, partially via CYP 3A4. Some instances of serum aminotransferase elevations occurring on haloperidol therapy may be due to nonalcoholic fatty liver disease caused by weight gain that occurs in at least one-quarter of treated patients, generally during the first 1 to 2 years of therapy.

### Outcome and Management

The serum aminotransferase elevations that occur on haloperidol therapy are usually self-limited and do not require dose modification or discontinuation of therapy. Instances of acute liver failure and at least one case of chronic cholestasis suggestive of vanishing bile duct syndrome due to haloperidol have been reported. Patients with haloperidol induced liver injury probably do not have cross sensitivity to liver injury from the atypical antipsychotics. However, haliperidol has been associated with DRESS syndrome and features of immunoallergic hepatitis that also occur with the aromatic anticonvulsants such as phenytoin, lamotrigine and carbamazepine, making it likely that there is some cross reactivity and potential for recurrence with those agents.

Drug Class: Antipsychotic Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Haloperidol – Generic, Haldol®, Peridol®

DRUG CLASS

Antipsychotic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Haloperidol)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Haloperidol | 52-86-8 | C21-H23-Cl-F-N-O2 | Haloperidol Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 25 March 2018

Zimmerman HJ. Neuroleptic drugs. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 483-91. (Expert review of hepatotoxicity of neuroleptic drugs including haloperidol published in 1999 mentions that at least 22 cases of jaundice due to haloperidol have been reported, usually cholestatic, rarely leading to vanishing bile duct syndrome; minor enzyme elevations occur in 20% of patients on haloperidol).
Larry D, Ripault MP. Hepatotoxicity of psychotropic drugs and drugs of abuse. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 443-62. (Review of hepatotoxicity of psychiatric agents mentions that rare cases of clinically apparent liver injury have been linked to haloperidol use, the usual clinical signature being cholestatic).
Meyer JM. Pharmacotherapy of psychosis and mania. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 417-55. (Textbook of pharmacology and therapeutics).
Crause J. Jaundice associated with haloperidol. Lancet 1963; 2: 890-1. Not in PubMed. (71 year old man with bronchitis and cor pulmonale developed jaundice 9 days after starting haloperidol [bilirubin not given; AST 120 U/L, Alk P 4 times ULN], jaundice resolving within 2 weeks of stopping).
Gerle B. Clinical observations of the side effects of haloperidol. Acta Psychiatr Scand 1964; 40: 65-76. (Review of 70 reports of adverse events from 6500 patients receiving haloperidol; despite several published cases of suspected haloperidol induced liver injury, relationship to drug is uncertain; 3 cases described by the author are interpreted as co-incidental and unrelated to use of haloperidol with no recurrence on restarting). 14211383
Crane GE. A review of clinical literature on haloperidol. Int J Neuropsychiat 1967; 3: Suppl 1: 110-27. (Review of 98 publications covering 5300 patients; liver impairment was reported in 13 cases, 9 with jaundice or severe hepatitis for a clinically apparent hepatotoxicity rate of ~1:500). 4860978
Gerle B. European experience with haloperidol. Int J Neuropsychiat 1967; 3: S42-52. (Discussion of review by Crane [1967] mentioning that no evidence of significant liver injury was found in a retrospective review of 500 patients followed prospectively with “complete laboratory investigations”, which led the authors to conclude that routine monitoring was unnecessary). 4860980
Fuller CM, Yassinger S, Donlon P, Imperato TJ, Ruebner B. Haloperidol-induced liver disease. West J Med 1977; 127: 515-8. (Two cases; 33 year old woman developed jaundice, rash and fever 5 weeks after restarting haloperidol [bilirubin 4.2 mg/dL, ALT 130 U/L, Alk P 486 U/L, eosinophils 3%], ultimately resolving when drug was stopped; 27 year old woman developed jaundice 4 weeks after starting haloperidol [bilirubin 15.8 mg/dL, AST 85 U/L, Alk P 310 U/L], no rash or fever, resolving within 4 weeks of stopping). 595591
Dincsoy HP, Saelinger DA. Haloperidol-induced chronic cholestatic liver disease. Gastroenterol 1982; 83: 694-700. (15 year old man developed acute cholestatic hepatitis 4 weeks after starting haloperidol [bilirubin 10.8 mg/dL, ALT 99 U/L, Alk P 370 U/L, eosinophils 8%], which evolved into chronic cholestasis with jaundice and pruritus for 7 months, biopsy showing paucity of bile ducts and bridging fibrosis, but with ultimate recovery except for mild Alk P elevations 28 months later). 7095372
Allison DB, Mentore JL, Heo M, Chandler LP, Cappelleri JC, Infante MC, Weiden PJ. Antipsychotic-induced weight gain: a comprehensive research synthesis. Am J Psychiatry 1999; 156: 1686-96. (Systematic review of 81 articles on weight change with antipsychotics, using change after 10 weeks to compare agents: clozapine +5.7, olanzapine +4.2, chlorpromazine +4.2, risperidone +1.7, loxapine +0.6, haloperidol +0.5, ziprasidone +0.3, molindone -0.1, and pimozide -2.7 kgs). 10553730
Gaertner I, Altendorf K, Batra A, Gaertner HJ. Relevance of liver enzyme elevations with four different neuroleptics: a retrospective review of 7,263 treatment courses. J Clin Psychopharmacol 2001; 21: 215-22. (Retrospective review of 233 inpatients treated with antipsychotic agents between 1980-92; some increase in ALT occurred in 78% of patients on clozapine and 50% on haloperidol; 3-fold increase occurred in ALT in 15% with clozapine and 2.4% with haloperidol; rates of 2-fold Alk P elevations were even lower [1% and 0.8%]). 11270919
Bender S, Grohmann R, Engel RR, Degner D, Dittmann-Balcar A, Ruther E. Severe adverse drug reactions in psychiatric inpatients treated with neuroleptics. Pharmacopsychiatry 2004; 37 (Suppl 1): S46-53. (Severe adverse drug reactions among 35,293 inpatients; adverse events more common with atypicals [0.5-0.9%] than typical antipsychotics [0.02-0.2%]; increased liver enzymes most common adverse reaction to olanzapine, 4th in frequency to clozapine, 6th to haloperidol, 7th to risperidone; no mention of hepatitis or acute liver failure). 15052514
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease collected between 2004 and 2008 in the US, several antidepressants [duloxetine, sertaline, fluoxetine, amitryptilline], but none of the antipsychotic agents, were implicated). 18955056
Torrent C, Amann B, Sanchez-Moreno J, Colom F, Feinares M, Comes M, Rosa AR, et al. Weight gain in bipolar disorder: pharmacological treatment as a contributing factor. Acta Psychiatr Scand 2008; 118: 4-18. (Review of frequency of weight gain in patients treated for bipolar disorders, most weight gain occurred with clozapine and olanzapine, but some weight gain also with quetiapine, risperidone, lithium, valproate and gabapentin; lesser amounts with haloperidol and not with carbamazepine or lamotrigine). 18498432
Parsons B, Allison DB, Loebel A, Williams K, Giller E, Romano S, Siu C. Weight effects associated with antipsychotics: a comprehensive database analysis. Schizophr Res 2009; 110: 103-10. (Analysis of weight gain in 21 placebo controlled trials of various antipsychotics [~3300 patients]; average monthly weight gain in pounds was +0.1 with placebo, +0.8 olanzapine, +0.6 risperidone, -0.3 ziprasidone; a 5% increase in weight occurred after one year in 13% of placebo, 39% haloperidol, 20% ziprasidone, 45% risperidone and 60% olanzapine treated subjects). 19321312
Lin CH, Kuo CC, Chou LS, Chen YH, Chen CC, Huang KH, Lane HY. A randomized, double-blind comparison of risperidone versus low-dose risperidone plus low-dose haloperidol in treating schizophrenia. J Clin Psychopharmacol 2010; 30: 518-25. (Controlled trial of 6 weeks of risperidone alone vs lower dose risperidone and haloperidol in 88 patients with schizophrenia; no change in mean ALT or AST levels in either group and no mention of hepatotoxicity). 20814315
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury including 4 due to psychotropic agents; one each for quetiapine, nefazodone, fluoxetine and venlafaxine, but none for phenothiazines or haloperidol). 20949552
Molleston JP, Fontana RJ, Lopez MJ, Kleiner DE, Gu J, Chalasani N; Drug-induced Liver Injury Network. Characteristics of idiosyncratic drug-induced liver injury in children: results from the DILIN prospective study. J Pediatr Gastroenterol Nutr 2011; 53: 182-9. (Among 30 children with suspected drug induced liver injury, half [n=15] were due to antimicrobials [minocycline 4, INH 3, azithromycin 3] and the rest largely due to CNS agents and anticonvulsants; one case was attributed to perphenazine, but none to haloperidol). 21788760
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period including one non-fatal but icteric case due to chlorpromazine, but none were attributed to haloperidol). 23419359
Fukata S, Kawabata Y, Fujisiro K, Katagawa Y, Kuroiwa K, Akiyama H, Terabe Y, et al. Haloperidol prophylaxis does not prevent postoperative delirium in elderly patients: a randomized, open-label prospective trial. Surg Today 2014; 44: 2305-13. (Among 121 elderly patients [75 years or older] undergoing surgery treated with haloperidol [2.5mg daily] or placebo for 3 days, rates of postoperative psychosis were similar as were adverse event rates; no mention of ALT elevations or hepatotoxicity). 24532143
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, but none were attributed to haloperidol). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/25754159) (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 5 cases [0.6%] were attributed to antipsychotic agents including 3 to quetiapine and 12 to olanzapine, but none to haloperidol or other first generation antipsychotics).
Douros A, Bronder E, Andersohn F, Klimpel A, Thomae M, Sarganas G, Kreutz R, et al. Drug-induced liver injury: results from the hospital-based Berlin Case-Control Surveillance Study. Br J Clin Pharmacol 2015; 79: 988-99. (Among 76 cases of suspected drug induced liver injury and 377 controls enrolled in a German, prospective hospital based registry, 6 cases [8%] but only 4 controls [1%] were receiving haloperidol, although the difference was said to be not significant). 25444550
Drugs for psychotic disorders. Med Lett Drugs Ther 2016; 58 (1510): 160-4. (Concise review of medications available in the US for therapy of psychotic disorders; mentions that haloperidol is a first generation agent which are all associated with adverse events of sexual dysfunction, neuroleptic malignant syndrome, extrapyramidal symptoms, akathisia and tardive dyskinesia; no mention of ALT elevations or hepatotoxicity). 27960194
Gründer G, Heinze M, Cordes J, Mühlbauer B, Juckel G, Schulz C, Rüther E, et al; NeSSy Study Group. Effects of first-generation antipsychotics versus second-generation antipsychotics on quality of life in schizophrenia: a double-blind, randomised study. Lancet Psychiatry 2016; 3: 717-29. (Among 149 patients started on either first- [haloperidol or flupentixol] or second-generation antipsychotics [olanzapine, quetiapine, aripiprazole] for 24 weeks, response rates were similar as were adverse events, weight gain being highest with olanzapine, quetiapine and haloperidol; median ALT and AST levels did not change significantly in any group). 27265548

## OTHER REFERENCE LINKS

1. Recent References on Haloperidol: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Haloperidol/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Haloperidol: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Haloperidol)